# Remdesivir

## OVERVIEW

### Introduction

Remdesivir is an antiviral nucleotide analogue used for therapy of severe novel coronavirus disease 2019 (COVID-19) caused by severe acute respiratory syndrome (SARS) coronavirus 2 (CoV-2) infection. Remdesivir therapy is given intravenously for 3 to 10 days and is frequently accompanied by transient, reversible mild-to-moderate elevations in serum aminotransferase levels but has been only rarely linked to instances of clinically apparent liver injury, its hepatic effects being overshadowed by the systemic effects of COVID-19.

### Background

Remdesivir (rem de’ si vir) is a phosphoramidate prodrug of a substituted nucleotide analogue of adenosine which has potent activity against the SARS-CoV-1 and SARS-CoV-2 encoded RNA dependent RNA polymerases. Remdesivir is not well absorbed orally and must be given by intravenous infusion. Once absorbed into cells, remdesivir is modified by cellular esterases and then converted by kinases to the active triphosphate, which competes with ATP for incorporation into the nascent viral RNA chain resulting in “delayed” chain termination. In animal models of SARS-CoV-2 infection, prophylactic or early treatment with remdesivir ameliorated the subsequent viral infection and clinical disease. In a large, multinational randomized, placebo-controlled trial in humans, remdesivir was found to shorten the time to clinical recovery in patients hospitalized with COVID-19, but had little effect on overall mortality. In other studies, the effects of remdesivir on time to recovery were less clear and mortality rates as well as SARS-CoV-2 RNA levels were similar to those on placebo or no therapy. Soon after the initial favorable reports of remdesivir therapy of severe COVID-19, it received emergency use authorization (EUA) approval for therapy of patients hospitalized with severe COVID-19 which was later extended to all hospitalized patients with COVID-19, both adults and children. After the final results were obtained and a more in-depth review, remdesivir was given formal approval for use in hospitalized adults and children (12 years of age or older and above 40 kilograms in weight) with COVID-19. In early 2022, reports of successful prevention of progression of COVID-19 with early therapy of outpatients with confirmed SARS-CoV-2 infection led to the EUA of remdesivir for this indication in children 12 years of age or older and adults with symptomatic COVID-19 infection who are at high risk of complications. Therapy is recommended within 7 days of onset. Remdesivir is available in single-use vials of 100 mg, both as lyophilized powder and in solution (5 mg/mL) under the brand name Veklury. The typical intravenous dose in adults and children above the age of 12 is 200 mg on day one and 100 mg once daily thereafter for 5 to 10 days in hospitalized patients with COVID-19 pneumonia and for 3 days in outpatients with early symptomatic disease. Adverse events of remdesivir therapy include mild-to-moderate degrees of nausea and vomiting, headache, fatigue, renal dysfunction, serum aminotransferase elevations and rash. Rare instances of hypersensitivity reactions, acute renal dysfunction and liver injury have been reported.

### Hepatotoxicity

In human volunteer studies, remdesivir therapy given for 7 to 14 days was associated with minor serum aminotransferase elevations (less than 5 times ULN) but without other evidence of hepatic injury. In controlled trials of remdesivir in patients hospitalized with COVID-19, rates of serum ALT elevations were similar or lower in patients receiving remdesivir than in those on placebo. Nevertheless, in most uncontrolled studies and case series, between 10% and 50% of patients treated with remdesivir developed transient, mild-to-moderate serum ALT and AST elevations within 1 to 5 days of starting therapy without changes in serum bilirubin or alkaline phosphatase levels. Elevations above 5 times ULN were reported in up to 9% of patients in several clinical trials, but the abnormalities resolved with discontinuation and were not associated with clinically apparent injury. With more widespread use of remdesivir for COVID-19, rare instances of marked ALT elevations with jaundice have been reported, but largely in patients who were critically ill with multi-organ failure or sepsis, or who had received other potentially hepatotoxic agents such as intravenous amiodarone (Case 2). Confounding the issue is that serum aminotransferase elevations are common during symptomatic SARS-CoV-2 infection (Case 1), present in up to 60% of patients and being more frequent in patients with severe disease and in those with the known risk factors for COVID-19 severity such as male sex, older age, higher body mass index and diabetes. Thus, serum aminotransferase elevations are common during remdesivir therapy but are generally asymptomatic, fully reversible and not associated with jaundice. With more widespread use of this antiviral in patients without severe or critical illness and with longer courses of therapy, features of hepatotoxicity may become more evident.

Likelihood score: D (possible uncommon cause of clinically apparent liver injury).

### Mechanism of Injury

Serum aminotransferase elevations are not uncommon with parenterally administered remdesivir and may be caused by direct toxicity possibly due to inhibition of mitochondrial RNA polymerase. On the other hand, idiosyncratic injury due to remdesivir has not been clearly shown. SARS-CoV-2 virus may infect the liver and has been identified in hepatocytes by molecular techniques and electron microscopy, but the associated liver injury in these cases was mild. The receptor for SARS-CoV-2, the angiotensin-converting enzyme 2 (ACE2), is found on the surface of hepatocytes, although it is present in higher density on cholangiocytes. In the liver, remdesivir is metabolized by and is a substrate for CYP 3A4. It is also a substrate of the hepatocyte transporters p-glycoprotein and OATP1B1 and thus may be susceptible to drug-drug interactions with agents that inhibit or induce these enzymes and transporters.

### Outcome and Management

The ALT and AST elevations associated with initiation of remdesivir therapy in patients with SARS-CoV-2 infection are generally mild-to-moderate in severity and self-limited in course without jaundice or symptoms. Careful monitoring of liver tests is recommended before and frequently during treatment. However, this recommendation is difficult in outpatient situations when the drug is given for 3 days only. Nevertheless, it is recommended that de novo elevations in ALT or AST above 10 times the upper limit of normal should lead to consideration of early discontinuation of the infusions. Furthermore, development of symptoms of hepatitis or jaundice should lead to immediate discontinuation. Restarting treatment can be considered once enzyme levels fall sufficiently, if there is no jaundice or symptoms and with careful monitoring. Use of other known hepatotoxins or potent inhibitors of p-glycoprotein should be avoided during remdesivir therapy.

Drug Class: Antiviral Agents; Nucleoside Analogues

## CASE REPORTS

### Case 1. Acute anicteric hepatitis attributed to SARS-CoV-2 infection.(1)

A 59 year old woman with HIV infection (well controlled on antiretroviral therapy), hypertension, hyperlipidemia and Graves disease presented to an emergency room with fatigue and dark urine. She denied jaundice, abdominal pain, itching, rash or fever. Laboratory evaluation showed elevations in liver tests that had previously been normal including ALT 617 U/L, AST 1230 U/L, alkaline phosphatase 141 U/L, bilirubin 0.6 mg/dL, albumin 3.1 g/dL and INR 1.7. She had no history of liver disease or known recent exposures to viral hepatitis. Her other medications included Genoya (elvitegravir, cobicistat, emtricitabine and tenofovir alafenamide), clonidine, amlodipine, propranolol, hydrochlorothiazide, levothyroxine, fish oil and multivitamins. She was admitted for evaluation. She was afebrile and physical examination was normal. Tests for hepatitis A, B, C and E were negative as were assays for cytomegalovirus and Epstein Barr virus infection. Abdominal ultrasound showed a normal appearing liver without evidence of biliary obstruction or gallstones. A liver biopsy was not done. On hospital day 2 she developed fever and was found to have an oxygen saturation of 94% on room air. A nasopharyngeal swab was taken and proved to be positive for SARS-CoV-2 viral RNA. She was treated with hydroxychloroquine and remained minimally symptomatic and was discharged on hospital day 8, liver test abnormalities having improved but remaining mildly elevated.

#### Key Points

Medication: | Not applicable
Pattern: | Hepatocellular (R=12.3)
Severity: | Mild (anicteric)
Latency: | Not applicable
Recovery: | Unclear
Other medications: | Clonidine, hydrochlorothiazide, emtricitabine, tenofovir, elvitegravir, cobicistat

#### Laboratory Values

Day of Hospitalization | ALT (U/L) | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
1 | 697 | 1230 | 141 | 0.6 | INR 1.08
2 | 675 | 1020 | 145
3 | 690 | 1125 | 195
4 | 640 | 820 | 201
5 | 530 | 605 | 205
6 | 480 | 480 | 230
7 | 370 | 205 | 259
8 | 227 | 110 | 250 | 0.6 | INR 1.13, discharged
Normal | <50 | <50 | <125 | <1.2

#### Comment

This 59 year old woman developed an acute, mildly symptomatic hepatitis during an early, presymptomatic phase of SARS-CoV-2 infection. Other causes of acute liver injury were excluded and the episode was attributed to the SARS-CoV-2 infection. A striking finding was the predominance of AST over ALT elevations, a pattern that occurs with acute alcoholic hepatitis but is rare in acute hepatocellular injury due to medications or viral hepatitis. On the other hand, the aminotransferases were higher and the time to recovery was more rapid than occurs typically in acute alcoholic hepatitis. The case report did not mention alcohol use and liver biopsy was not done. One possible explanation for the prominent AST elevation was that part of the injury was due to muscle involvement. Transient elevations in serum aminotransferase levels are not uncommon during the course of symptomatic COVID-19 and in some cases AST elevations are greater than those of ALT. The degree of severity of the liver injury usually correlates with the degree of severity of the SARS-CoV-2 infection and occurs most frequently in men, the elderly and persons with obesity and diabetes. The occurrence of hepatic injury during the course of COVID-19 makes diagnosis of drug induced injury from therapies such as remdesivir challenging.

### Case 2. Marked serum aminotransferase elevations and jaundice during remdesivir therapy of SARS-CoV-2 infection.(2)

A 68 year old woman with hypertension, diabetes, hyperlipidemia and coronary artery disease developed shortness of breath and chest pain and was hospitalized with suspected COVID-19 pneumonia. She was hypoxemic and had diffuse interstitial infiltrates but nasopharyngeal samples were negative for SARS-CoV-2 RNA. She had worsening symptoms and on day 4 underwent cardiac catheterization which showed severe, multivessel coronary artery disease. On day 6 she underwent successful 4-vessel coronary artery bypass surgery, but a repeat nasopharyngeal sample taken that day was positive for SARS-CoV-2, and she was transferred to a COVID-19 ward. Over the next few days, she had worsening oxygen requirements and pulmonary infiltrates and was started on remdesivir (200 mg loading dose followed by 100 mg daily intravenously). The following day she developed atrial fibrillation and was started on amiodarone infusions (150 mg loading dose, followed by 6 hours of 1.0 mg/min, followed by maintenance dosing of 0.5 mg/min). One day later serum ALT levels were above 5000 U/L and both remdesivir and amiodarone were stopped and intravenous N-acetyl cysteamine (iv NAC) was given. Her liver tests improved over the ensuing few days (Table) and she was discharged 2 weeks later.

#### Key Points

Medication: | Remdesivir
Pattern: | Hepatocellular (R=~100)
Severity: | Moderate
Latency: | 2 days
Recovery: | Improvements over next two weeks
Other medications: | Amiodarone intravenously

#### Laboratory Values

Time After Starting | ALT (U/L) | AST (U/L) | Bilirubin (mg/dL) | Other
-7 days | 21 | | | Admitted with shortness of breath
-4 days | 15
Day 1 | - | | | Started remdesivir
Day 2 | 115 | | | Started amiodarone
Day 3 | >5000 | >5000 | 3.1 | INR 2.3: stopped drugs; IV NAC given
Day 4 | 2825 | >5000 | | IV NAC given
Day 5 | 1861 | 1348
Day 7 | 966 | 235 | 2.1
Day 9 | 469
Day 11 | 211
Day 13 | 120
Day 17 | 50 | | Normal | INR normal, discharged
Normal | Not given | Not given | <1.2

#### Comment

A 68 year old woman suffered an acute coronary syndrome complicated by concurrent COVID-19. Therapy with remdesivir and amiodarone was rapidly followed by marked elevations in serum ALT and AST which fell after stopping both drugs (and administration of N-acetylcysteine). The marked elevations in both ALT and AST within 2 days of starting remdesivir is distinctly unusual and might well have been due to amiodarone that was started at about the same time. One possible explanation for the severity of the injury is that amiodarone altered the pharmacokinetics of remdesivir which is secreted from hepatocytes by p-glycoprotein, a hepatic transporter which is inhibited by amiodarone. A similar drug-drug interaction with precipitous adverse events occurs with the combination of sofosbuvir (another nucleoside analogue inhibitor of a viral RNA polymerase) and amiodarone, which results in severe bradycardia. Another explanation for the marked aminotransferase elevations would be shock, hypotension or hypoxemia which would cause acute hepatic necrosis. The case report is also somewhat unclear in regard to timing of the medications and the laboratory results.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Remdesivir – Veklury ®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Remdesivir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Remdesivir | 1809249-37-3 | C27-H35-N6-O8-P

## CITED REFERENCES

1 Wander P, Epstein M, Bernstein D. (2020). COVID-19 presenting as acute hepatitis. Am J Gastroenterol.
2 Carothers C, Birrer K, Vo M. (2020). Acetylcysteine for the treatment of suspected remdesivir-associated acute liver failure in COVID-19: a case series. Pharmacotherapy.

## ANNOTATED BIBLIOGRAPHY

References updated: 03 February 2022

Núñez M. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 505-18. (Review of hepatotoxicity of antiviral agents, long before the appearance of COVID 19 and availability of remdesivir).
Flexner C. Antiretroviral agents and treatment of HIV infection. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1137-58. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/214787Orig1s000Sumr.pdf (FDA summary review of the safety and efficacy of remdesivir as therapy of COVID-19 ).
Feng JY, Xu Y, Barauskas O, Perry JK, Ahmadyar S, Stepan G, Yu H, et al. (2015). Role of mitochondrial RNA polymerase in the toxicity of nucleotide inhibitors of hepatitis C virus. Antimicrob Agents Chemother. (The major reason for failure of drugs in clinical development is toxicity, and the major concern for viral RNA polymerase inhibitors is mitochondrial toxicity caused by susceptibility of mitochondrial RNA polymerase [which lacks proofreading activity], which nevertheless can be assessed in vitro).
Huang C, Wang Y, Li X, Ren L, Zhao J, Hu Y, Zhang L, et al. (2020). Clinical features of patients infected with 2019 novel coronavirus in Wuhan, China. Lancet. (Among 41 adults with COVID-19 pneumonia hospitalized in Wuhan, China in December 2019 to January 2020, 37% had serum AST elevations [62% of those in the ICU and 25% of those not], with concurrent elevations in proinflammatory cytokines [IL1B, IL6, IL2, IFN gamma] and 15% died).
Guan WJ, Ni ZY, Hu Y, Liang WH, Ou CQ, He JX, Liu L, et al., China Medical Treatment Expert Group for COVID-19. (2020). Clinical characteristics of coronavirus disease 2019 in China. N Engl J Med. (Among 1099 patients hospitalized with COVID-19 at 552 hospitals in China through January 2020, the median age was 47 years, 42% were women, 2.4% were admitted to an ICU, 1.4% died and ALT elevations arose in 4.1%).
Zhang C, Shi L, Wang FS. (2020). Liver injury in COVID-19: management and challenges. Lancet Gastroenterol Hepatol. (Editorial on the frequency and causes of liver test abnormalities in patients with SARS-CoV-2 infection, the most frequent abnormalities being elevations in serum ALT or AST that are reported in 14-53% of patients and are more frequent in patients with severe disease).
Xu L, Liu J, Lu M, Yang D, Zheng X. (2020). Liver injury during highly pathogenic human coronavirus infections. Liver Int. (Review of the literature on clinical features and causes of liver injury associated with severe coronavirus infections, reports that transient, largely asymptomatic increases in serum ALT and AST without bilirubin or Alk P elevations arose in 53-87% of SARS-CoV-1, 56% of MERS, and 11-28% of SARS-CoV-2 infections, but that clinically apparent liver injury was uncommon).
Gordon CJ, Tchesnokov EP, Woolner E, Perry JK, Feng JY, Porter DP, Götte M. (2020). Remdesivir is a direct-acting antiviral that inhibits RNA-dependent RNA polymerase from severe acute respiratory syndrome coronavirus 2 with high potency. J Biol Chem. (In vitro demonstration of the antiviral activity of remdesivir against the SARS-CoV-1 and SARS-CoV-2 RNA dependent RNA polymerases, showing the viral polymerase has preference for incorporating remdesivir-triphosphate over ATP into the growing RNA molecule which causes delayed chain termination).
Grein J, Ohmagari N, Shin D, Diaz G, Asperges E, Castagna A, Feldt T, et al. (2020). Compassionate use of remdesivir for patients with severe COVID-19. N Engl J Med. (Among 53 patients with SARS-CoV-2 pneumonia treated with remdesivir for up to 10 days, clinical improvement was achieved in 84% of patients by day 28 while 60% had adverse events including 12 [23%] with serum aminotransferase elevations which were typically transient and mild).
Wander P, Epstein M, Bernstein D. (2020). COVID-19 presenting as acute hepatitis. Am J Gastroenterol. (59 year old woman with HIV infection developed fatigue and jaundice [bilirubin 0.6 mg/dL, ALT 697 U/L, Alk P 145 U/L, INR 1.08] and then developed fever and cough with positive tests for SARS-CoV-1, liver tests falling over the next week as she recovered from COVID-19, Case 1).
Qiu H, Wander P, Bernstein D, Satapathy SK. (2020). Acute on chronic liver failure from novel severe acute respiratory syndrome coronavirus 2 (SARS-CoV-2). Liver Int. (56 year old woman with decompensated alcoholic cirrhosis developed worsening jaundice and liver function when admitted with SARS-CoV-2 infection [bilirubin rising from 9.4 to ~17.8 mg/dL, ALT from 94 to ~275 U/L, AST from 184 to ~880 U/L, Alk P from 128 to ~195 U/L, INR from 1.9 to 2.6], liver tests improving towards baseline as the infection resolved).
Sise ME, Baggett MV, Shepard JO, Stevens JS, Rhee EP. (2020). Case 17-2020: a 68-year-old man with Covid-19 and acute kidney injury. N Engl J Med. (68 year old man with diabetes, hypertension and coronary artery disease developed COVID-19 pneumonia and was treated with remdesivir and hydroxychloroquine and developed worsening renal function [creatinine rising from 1.3 to 6.9 mg/dL] leading to early discontinuation of therapy and initiation of hemodialysis, but ultimately recovering, attributed to direct renal effects of the SARS-CoV-1 infection).
Jorgensen SCJ, Kebriaei R, Dresser LD. (2020). Remdesivir: review of pharmacology, pre-clinical data, and emerging clinical experience for COVID-19. Pharmacotherapy. (Review of the chemistry, pharmacology, antiviral activity, resistance patterns of remdesivir as well as studies in animal models and human volunteers and early results of safety and efficacy in clinical trials).
Williamson BN, Feldmann F, Schwarz B, Meade-White K, Porter DP, Schulz J, van Doremalen N, et al. (2020). Clinical benefit of remdesivir in rhesus macaques infected with SARS-CoV-2. Nature. (In a rhesus macaque model of SARS-CoV-2 infection, intravenous administration of remdesivir starting within 12 hours of inoculation, attenuated the pulmonary complications and lowered viral levels in the lungs but not in the upper respiratory tract).
Antinori S, Cossu MV, Ridolfo AL. (2020). Compassionate remdesivir treatment of severe COVID-19 pneumonia in intensive care unit (ICU) and non-ICU patients: clinical outcome and differences in post-treatment hospitalisation status. Pharmacol Res. (Among 35 patients with severe SARS-CoV-2 pneumonia treated with a 10 day course of remdesivir, ALT or AST elevations above 3 times ULN occurred in 15 patients [43%] and led to early discontinuation in 3 [9%]).
Durante-Mangoni E, Andini R, Bertolino L, Mele F, Florio LL, Murino P, Corcione A, et al. (2020). Early experience with remdesivir in SARS-CoV-2 pneumonia. Infection. (Among 4 patients with severe SARS-CoV-2 pneumonia treated with remdesivir for up to 10 days, 3 developed ALT and AST elevations ranging from 5 to 8 times ULN; no mention of clinically apparent liver injury).
Wang Y, Zhang D, Du G, Du R, Zhao J, Jin Y, Fu S, et al. (2020). Remdesivir in adults with severe COVID-19: a randomised, double-blind, placebo-controlled, multicentre trial. Lancet. (Among 237 patients with SARS-CoV-2 pneumonia with hypoxemia treated with remdesivir vs placebo for 10 days, the two groups had similar times to improvement [21 vs 23 days], 28 day mortality [14% vs 13%], rates of decline in viral levels and overall adverse event rates [66% vs 64%], while AST elevations were less with the active drug [5% vs 12%]).
Ridruejo E, Soza A. (2020). The liver in times of COVID-19: What hepatologists should know. Ann Hepatol. (Review of the effects of preexisting liver disease on the severity and outcome of COVID-19 as well as the frequency and significance of liver test abnormalities in patients with SARS-CoV-2 infection and the potential of hepatotoxicity of drugs used in its therapy).
Boulware DR, Pullen MF, Bangdiwala AS, Pastick KA, Lofgren SM, Okafor EC, Skipper CP, et al. (2020). A Randomized trial of hydroxychloroquine as postexposure prophylaxis for COVID-19. N Engl J Med. (Among 821 patients with exposure to COVID-19 treated with oral hydroxychloroquine or placebo for 5 days, rates of new illness compatible with COVID-19 were similar in the two groups [14% vs 12%] while adverse events were more frequent with hydroxychloroquine [40% vs 17%]; ALT elevations were not mentioned).
Leegwater E, Strik A, Wilms EB, Bosma LBE, Burger DM, Ottens TH, van Nieuwkoop C. (2021). Drug-induced liver injury in a COVID-19 patient: potential interaction of remdesivir with P-glycoprotein inhibitors. Clin Infect Dis. (64 year old man with severe SARS-CoV-2 pneumonia developed elevations in serum aminotransferases 5 days after starting remdesivir and 2 days after starting amiodarone [bilirubin 0.5 mg/dL, ALT 135 U/L, Alk P 267 U/L], improving rapidly with stopping, the authors suggested that inhibition of p-glycoprotein, the major hepatic transporter of remdesivir, may have led to its accumulation to injurious levels in hepatocytes).
Dubert M, Visseaux B, Isernia V, Bouadma L, Deconinck L, Patrier J, Wicky PH, et al. (2020). Case report study of the first five COVID-19 patients treated with remdesivir in France. Int J Infect Dis. (Among 5 French patients with SARS-CoV-2 pneumonia treated with remdesivir, 2 died and 3 had a favorable outcome, while 4 had significant adverse reactions including acute renal injury in two and maculopapular rash and liver test abnormalities in 2 [ALT 195 U/L on day 4 and 116 U/L on day 8), resolving within 3-5 days of stopping).
Beigel JH, Tomashek KM, Dodd LE, Mehta AK, Zingman BS, Kalil AC, Hohmann E, et al., ACTT-1 Study Group Members. (2020). Remdesivir for the treatment of Covid-19 - final report. N Engl J Med. (Among 1062 patients hospitalized with COVID-19 treated with intravenous remdesivir or placebo for 10 days, median recovery time was shorter with remdesivir [10 vs 15 days] and adverse events were less common [21% vs 27%], including ALT or AST elevations [6% vs 10.7%].
Bertolini A, van de Peppel IP, Bodewes FAJA, Moshage H, Fantin A, Farinati F, Fiorotto R, et al. (2020). Abnormal liver function tests in COVID-19 patients: relevance and potential pathogenesis. Hepatology. (Review of the prevalence and potential causes of abnormal liver tests in patients with SARS-CoV-2 infection, ALT elevations being reported in 4% to 39% of patients with higher rates in patients with more severe disease).
Javorac D, Grahovac L, Manić L, Stojilković N, Anđelković M, Bulat Z, Đukić-Ćosić D, et al. (2020). An overview of the safety assessment of medicines currently used in the COVID-19 disease treatment. Food Chem Toxicol. (Review of the toxicities of drugs used experimentally to treat SARS-CoV-2 infection mentions that remdesivir can cause reversible elevations in serum ALT and AST, but without concurrent increases in Alk P or bilirubin levels).
Fan Q, Zhang B, Ma J, Zhang S. (2020). Safety profile of the antiviral drug remdesivir: An update. Biomed Pharmacother. (Short review of the safety of remdesivir identified in early studies of its use in patients with severe COVID-19 mentions that serum aminotransferase elevations are not uncommon during SARS-CoV-2 pneumonia and several reports have reported transient, elevations of serum ALT and AST levels without symptoms or jaundice during remdesivir therapy).
Montastruc F, Thuriot S, Durrieu G. (2020). Hepatic disorders with the use of remdesivir for coronavirus 2019. Clin Gastroenterol Hepatol. (A total of 387 spontaneous adverse drug reactions attributed to remdesivir have been reported to VigiBase, 130 being hepatic, 88 being serum ALT elevations, arising after 1-11 days, lasting an average of 3.8 days).
Zampino R, Mele F, Florio LL, Bertolino L, Andini R, Galdo M, De Rosa R, et al. (2020). Liver injury in remdesivir-treated COVID-19 patients. Hepatol Int. (Among 5 critically ill patients with SARS-CoV-2 infection, all had increases in ALT or AST without Alk P or bilirubin elevations within 1-3 days of starting remdesivir, resolving rapidly with stopping and not associated with clinically apparent liver injury or jaundice).
Hundt MA, Deng Y, Ciarleglio MM, Nathanson MH, Lim JK. (2020). Abnormal liver tests in COVID-19: A retrospective observational cohort study of 1827 patients in a major U.S. hospital network. Hepatology. (Among 1877 patients hospitalized with SARS-CoV-2 infection, serum ALT levels were elevated before hospitalization in 19%, at admission in 42% and at peak during hospitalization in 62% with 21% being greater than 5 times ULN; elevations correlated with disease severity and its risk factors, male sex, older age, higher BMI and diabetes).
Cavalcanti AB, Zampieri FG, Rosa RG, Azevedo LCP, Veiga VC, Avezum A, Damiani LP, et al. (2020). Coalition COVID-19 Brazil I Investigators. Hydroxychloroquine with or without azithromycin in mild-to-moderate COVID-19. N Engl J Med. (Among 504 hospitalized patients with confirmed COVID-19 who were treated with standard of care or hydroxychloroquine or with combination of hydroxychloroquine and azithromycin for 7 days, improvement in clinical status by day 15 was similar in all three groups, while ALT elevations were more frequent in those receiving hydroxychloroquine [11% and 9%] than in those given neither [3.4%]).
Lee C, Ahn MY, Byeon K, Choi JP, Hahm C, Kim H, Kim S, et al. (2020). Clinical experience with use of remdesivir in the treatment of severe acute respiratory syndrome coronavirus 2: a case series. Infect Chemother. (Among 10 Korean patients with severe SARS-CoV-2 pneumonia treated for 5 or 10 days with remdesivir, 5 developed ALT and AST elevations, but all were transient and less than 5 times ULN).
Spinner CD, Gottlieb RL, Criner GJ, Arribas López JR, Cattelan AM, Soriano Viladomiu A, Ogbuagu O, et al. (2020). GS-US-540-5774 Investigators. Effect of remdesivir vs standard care on clinical status at 11 days in patients with moderate COVID-19: a randomized clinical trial. JAMA. (Among 584 patients hospitalized with confirmed SARS-CoV-2 pneumonia, clinical improvements at day 11 were more frequent in patients randomized to 5 days of remdesivir vs 10 days of remdesivir and vs standard of care [70% vs 65% vs 61%], while 28 day mortality was similar in all 3 groups [1% vs 2% vs 2%], although severe adverse events were less in those on remdesivir [5% vs 5% vs 9%] including any ALT elevation [34% vs 32% vs 39%] and those above 5 times ULN [2% vs 3% vs 8%]; no mention of clinically apparent hepatotoxicity).
Ferron PJ, Gicquel T, Mégarbane B, Clément B, Fromenty B. (2020). Treatments in COVID-19 patients with pre-existing metabolic dysfunction-associated fatty liver disease: a potential threat for drug-induced liver injury?. Biochimie. (Commentary on possible hepatotoxicity of drugs used to treat SARS-CoV-2 infection and possible increase in risk for injury among patients with preexisting fatty liver disease).
Carothers C, Birrer K, Vo M. (2020). Acetylcysteine for the treatment of suspected remdesivir-associated acute liver failure in COVID-19: a case series. Pharmacotherapy. (Two patients, ages 68 and 80, with severe SARS-CoV-2 pneumonia developed abnormal liver tests during or shortly after a course of remdesivir, one arising 2 days after starting remdesivir and 1 day after starting intravenous amiodarone [Case 2: bilirubin 3.1 mg/dL, ALT 2400 U/L, INR 2.3], and one arising 4 days after stopping a 5 day course of remdesivir and concurrent with suspected septic shock [bilirubin 2.1 mg/dL, ALT 1510 U/L, Alk P 151 U/L, INR 1.7], both treated with acetylcysteine infusions with apparent improvement).
FDA Fact Sheet for Health Care Providers. Emergency use authorization (EUA) of Veklury® (remdesivir) https://www.fda.gov/media/137566/download (Fact sheet on remdesivir from the FDA recommends monitoring of routine liver tests before and daily during remdesivir therapy, not initiating therapy if values are above 5 times ULN and discontinuing therapy if they rise to above 5 times ULN, restarting when values fall below this level).
Horby P, Mafham M, Linsell L, Bell JL, Staplin N, Emberson JR, Wiselka M, et al., RECOVERY Collaborative Group. (2020). Effect of hydroxychloroquine in hospitalized patients with Covid-19. N Engl J Med. (Among 1561 patients randomized to receive hydroxychloroquine vs 3155 randomized to standard care, the mortality rate was similar in the two groups [27% vs 25%] and cardiovascular toxicity was not increased with the active drug; no mention of ALT elevations or hepatotoxicity).
Dyer O. (2020). Covid-19: Remdesivir has little or no impact on survival, WHO trial shows. BMJ. (Editorial on the results of the large WHO-supported Solidarity Trial comparing four different promising agents to no therapy in 11,266 adults hospitalized with COVID-19 demonstrating no difference in 28 day mortality with remdesivir therapy [301/2708: 11.1%] compared to no treatment [301/2743: 11.0%], nor in rates of requiring mechanical ventilation or in duration of hospitalization).
Baang JH, Smith C, Mirabelli C, Valesano AL, Manthei DM, Bachman M, Wobus CE, et al. (2021). Prolonged SARS-CoV-2 replication in an immunocompromised patient. J Infect Dis. (60 year old man with refractory lymphoma on chemotherapy [including mosunetuzumab] developed persistent SARS CoV-2 infection with repeated bouts of pulmonary symptoms and persistent nasopharyngeal RNA and virus [molecularly identical] despite two courses of remdesivir and convalescent plasma, being still SARS CoV-2 positive at 156 days when he was referred for hospice care).
Beigel JH, Tomashek KM, Dodd LE, Mehta AK, Zingman BS, Kalil AC, Hohmann E, et al., ACTT-1 Study Group Members. (2020). Remdesivir for the treatment of COVID-19 – final report. N Engl J Med. (Final report of a randomized, placebo controlled trial of remdesivir infusions for 10 days in 1062 adults hospitalized with COVID-19 pneumonia found treatment resulted in more rapid recovery time [10 vs 15 days] and slightly lower mortality at 29 days [11.4% vs 15.2%], while adverse events were less frequent with the active drug including serious adverse events [24% vs 32%], and elevations in serum ALT [2.3% vs 4.7%], AST [3.4% vs 6.4%] and bilirubin [1.7% vs 3.1%]; no mention of clinically apparent liver injury).
Goldman JD, Lye DCB, Hui DS, Marks KM, Bruno R, Montejano R, Spinner CD, et al. (2020). GS-US-540-5773 Investigators. Remdesivir for 5 or 10 days in patients with severe COVID-19. N Engl J Med. (Among 297 patients with severe SARS-CoV-2 pneumonia treated with 5 or 10 days of intravenous remdesivir, rates of clinical improvement were similar in the two groups and adverse events included nausea [9%], constipation [7%] and ALT elevations above 5 times ULN [7%]; therapy was discontinued early because of enzyme elevations in 3% but no mention of clinically apparent hepatotoxicity).
Humeniuk R, Mathias A, Cao H, Osinusi A, Shen G, Chng E, Ling J, Vu A, German P. (2020). Safety, tolerability, and pharmacokinetics of remdesivir, an antiviral for treatment of COVID-19, in healthy subjects. Clin Transl Sci. (Results of phase 1 studies of remdesivir in healthy subjects, found ALT or AST elevations in 2 subjects treated for 7 days and 6 of 8 treated for 14 days, but all elevations were asymptomatic, mild [less than 5 times ULN], transient and not associated with bilirubin or alkaline phosphatase elevations).
Zeitlinger M, Koch BCP, Bruggemann R, De Cock P, Felton T, Hites M, Le J, et al., PK/PD of Anti-Infectives Study Group (EPASG) of the European Society of Clinical Microbiology, Infectious Diseases (ESCMID). (2020). Pharmacokinetics/pharmacodynamics of antiviral agents used to treat SARS-CoV-2 and their potential interaction with drugs and other supportive measures: a comprehensive review by the PK/PD of Anti-Infectives Study Group of the European Society of Antimicrobial Agents. Clin Pharmacokinet. (Review of the pharmacology and potential of drug-drug interaction of remdesivir).
Sabers AJ, Williams AL, Farley TM. (2020). Use of remdesivir in the presence of elevated LFTs for the treatment of severe COVID-19 infection. BMJ Case Rep. (82 year old man with COVID-19 treated initially with hydroxychloroquine and azithromycin was admitted with pulmonary symptoms and found to have abnormal liver tests [bilirubin 1.1 mg/dL, ALT 1075 U/L, Alk P not given], which worsened for one day and then improved rapidly despite initiation of therapy with remdesivir as well as use of convalescent plasma, dexamethasone, levofloxacin, ceftriaxone and amiodarone [while stopping hydroxychloroquine and azithromycin], with clinical improvement and near normal ALT levels by day 7).
Rahimi MM, Jahantabi E, Lotfi B, Forouzesh M, Valizadeh R, Farshid S. (2021). Renal and liver injury following the treatment of COVID-19 by remdesivir. J Nephropathol. (Review of the renal handling of remdesivir and cautionary note on use of remdesivir in patients with renal dysfunction because of an increased risk of further renal dysfunction and hepatic adverse events).
Gupte V, Hegde R, Sawant S, Kalathingal K, Jadhav S, Malabade R, Gogtay J. (2022). Safety and clinical outcomes of remdesivir in hospitalised COVID-19 patients: a retrospective analysis of active surveillance database. BMC Infect Dis. (Among 2329 patients hospitalized with COVID-19 captured in an Indian surveillance database who were treated with remdesivir, therapy was “well tolerated overall” with only 119 adverse events reported, the most frequent being nausea and vomiting [45%] and liver enzyme elevations [14%], rash [6%] and nephrotoxicity [1.7%], but no specific details provided).
Marc F, Moldovan C, Hoza A, Restea P, Sachelarie L, Romila LE, Suteu C, et al. (2021). Evaluation of hepatic biochemical parameters during antiviral treatment in COVID-19 patients. Biology (Basel). (Among 272 adults hospitalized with COVID-19 in a Romania hospital and treated with various antiviral regimens, serum AST levels increased slightly during remdesivir therapy [51.1 to 52.1 U/L], but decreased to below baseline by the time of discharge and no patient developed serious liver injury).
Law MF, Ho R, Law KWT, Cheung CKM. (2021). Gastrointestinal and hepatic side effects of potential treatment for COVID-19 and vaccination in patients with chronic liver diseases. World J Hepatol. (Review of the gastrointestinal and hepatic side effects of drugs used to treat COVID-19 mentions that transient and mild ALT elevations arose in healthy controls receiving remdesivir, and elevations were observed in ~8% of recipients in controlled trials and up to 40% of critically ill patients in case series, but discontinuation for ALT elevations were rare and no case of clinically apparent liver injury was reported).
Kayaaslan B, Guner R. (2021). COVID-19 and the liver: A brief and core review. World J Hepatol. (Review of the hepatic manifestations and complications of COVID-19 mentions that abnormal liver tests are found in at least one-fourth of patients, most frequently in those with more severe disease, and can be due to cytokine storm, hypoxia, sepsis, the medications used to treat COVID-19, and possibly a direct cytopathic effect of the virus; yet the liver involvement is rarely severe and is typically overshadowed by other complications of COVID-19).
Ali K, Azher T, Baqi M, Binnie A, Borgia S, Carrier FM, Cavayas YA, et al.; Canadian Treatments for COVID-19 (CATCO); Association of Medical Microbiology and Infectious Disease Canada (AMMI) Clinical Research Network and the Canadian Critical Care Trials Group. Remdesivir for the treatment of patients in hospital with COVID-19 in Canada: a randomized controlled trial. CMAJ. 2022:cmaj.211698. (In a secondary analysis of Canadian subjects enrolled in the multinational pragmatic Solidarity Trial [2021], 1282 hospitalized patients with COVID-19 hospitalized in 52 Canadian centers received remdesivir or standard of care, in whom the 28 day mortality was 18.7% vs 22.6%, which was of borderline significance while mechanical ventilation was done in 8% vs 15%; no mention of adverse event rates, ALT elevations or hepatotoxicity).
Leo M, Galante A, Pagnamenta A, Ruinelli L, Ponziani FR, Gasbarrini A, De Gottardi A. Hepatocellular liver injury in hospitalized patients affected by COVID-19: Presence of different risk factors at different time points. Dig Liver Dis. 2021:S1590-8658(21)00923-3. (Among 292 adults admitted to 7 Swiss hospitals with COVID-19, 29% had ALT or AST elevations on admission, 6% of which were above 3 times ULN; elevations arose in 53% of those with initially normal values).
Gottlieb RL, Vaca CE, Paredes R, Mera J, Webb BJ, Perez G, Oguchi G, et al. (2022). GS-US-540-9012 (PINETREE) Investigators. Early remdesivir to prevent progression to severe Covid-19 in outpatients. N Engl J Med. (Among 562 non-hospitalized adults with symptomatic COVID-19 and at high risk for complications who were treated with remdesivir [200 mg day 1, 100 mg days 2 and 3] or placebo intravenously once daily, subsequent hospitalization for COVID 19 occurred in 2 remdesivir- vs 15 placebo-treated participants [0.7% vs 5.3%: 87% decline] and none died by day 28; while overall adverse event rates were similar in the 2 arms, the remdesivir treated patients had fewer severe adverse events; no mention of ALT elevations or hepatotoxicity).
(2022). COVID-19 updates. Med Lett Drugs Ther. (Concise review of EUA of remdesivir for prevention of progression of COVID-19 in outpatient adults and children [12 years or above] with symptomatic SARS-CoV-2 infection and who are within 7 days of onset and at high risk of complications; mentions that hypersensitivity reactions can occur, but does not mention ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Remdesivir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Remdesivir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Remdesivir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Remdesivir)